# Posaconazole

## OVERVIEW

### Introduction

Posaconazole is a potent triazole antifungal agent used in the prevention of invasive fungal infections due to aspergillosis and candida in high risk patients. Posaconazole therapy is associated with transient, asymptomatic serum aminotransferase elevations and is a suspected but rare cause of clinically apparent acute drug induced liver injury.

### Background

Posaconazole (poe" sa kon' a zole) is a synthetic triazole that is believed to act through inhibition of the fungal 14α-ergosterol demethylase, which is responsible for converting lanosterol to ergosterol and which blocks cell membrane synthesis. Posaconazole is active against a broad spectrum of fungal agents including Candida albicans and Aspergillus fumigatus. Posaconazole was approved for use in the United States in 2006. Current indications are oropharyngeal candidiasis and prophylaxis against invasive fungal infections in neutropenic or immunosuppressed patients. Posaconazole is available as a 100 mg delayed-release tablet and as an oral suspension of 40 mg/mL under the brand name Noxafil. A loading dose is recommended followed by maintenance doses of 100 to 300 mg daily; however, the dosage varies depending upon indications and the formulation used. Common side effects include nausea, vomiting, diarrhea, abdominal pain, headache, dizziness and rash.

### Hepatotoxicity

Transient elevations in serum aminotransferase levels occur in 2% to 12% of patients on posaconazole. These elevations are usually mild, asymptomatic and self-limited and rarely require discontinuation of the medication. Clinically apparent hepatotoxicity is very rare. Instances of jaundice and hepatitis during posaconazole therapy are mentioned in the product label, but little information was provided on clinical details.

Likelihood score: E* (unproved but suspected cause of clinically apparent liver injury).

### Mechanism of Injury

The cause of the liver injury from posaconazole is unknown; however, it may have some correlation to the ability of voriconazole to alter human sterol synthesis. Because posaconazole inhibits CYP 3A4 activity, it can cause significant drug-drug interactions and including elevations in plasma levels of other medications that are metabolized by this P450 enzyme, sometimes resulting in toxicity.

### Outcome and Management

The severity of the liver injury from posaconazole ranges from mild and transient enzyme elevations to hepatitis with jaundice. Fatal instances have not been described, but the drug has not been extensively used or studied. A single case report describes a patient with hepatotoxicity from voriconazole who was able to tolerate posaconazole without difficulty. Nevertheless, caution should be used in starting other azole antifungal agents in patients with clinically apparent liver injury due to ketoconazole, itraconazole, fluconazole or voriconazole.

Drug Class: Antifungal Agents

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Posaconazole – Noxafil®

DRUG CLASS

Antifungal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=posaconazole)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Posaconazole | 171228-49-2 | C37-H42-F2-N8-O4 | Image of Posaconazole Chemical Structure

## ANNOTATED BIBLIOGRAPHY

References updated: 17 May 2017

Zimmerman HJ. Antifungal agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 609-11. (Expert review of hepatotoxicity of antifungal agents published in 1999 before the availability of posaconazole).
Moseley RH. Antifungal agents. Antibacterial and antifungal agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 470-81. (Review of hepatotoxicity of antifungal agents ; mentions that asymptomatic elevations in liver enzymes occur in 5-15% of patients treated with posaconazole).
Bennett JE. Antimicrobial agents: antifungal agents. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 1571-92. (Textbook of pharmacology and therapeutics mentions that posaconazole is a synthetic analog of itraconazole with similar activity and a good safety profile).
Courtney R, Sansone A, Smith W, Marbury T, Statkevich P, Marinho M, Laughlin M, et al. Posaconazole pharmacokinetics, safety, and tolerability in subjects with varying degrees of chronic renal disease. J Clin Pharmacol 2005; 45: 185-92. (Single and multiple dose pharmacokinetic study of posaconazole in 24 patients with renal dysfunction; ALT elevations occurred in five patients, but only one without ALT elevations before therapy). 15647411
Vazquez JA, Skiest DJ, Tissot-Dupont H, Lennox JL, Boparai N, Isaacs R. Safety and efficacy of posaconazole in the long-term treatment of azole-refractory oropharyngeal and esophageal candidiasis in patients with HIV infection. HIV Clin Trials 2007; 8: 86-97. (Open label study of posaconazole in 90 patients with HIV infection and refractory oropharyngeal candidiasis; elevated ALT levels occurred in 3 of 51 [6%] on long term therapy and one developed jaundice). 17507324
Foo H, Gottlieb T. Lack of cross-hepatotoxicity between voriconazole and posaconazole. Clin Infect Dis 2007; 45: 803-5. (70 year old man developed cholestatic liver enzyme elevations within a month of starting amphotericin and voriconazole [bilirubin normal, Alk P 1210 U/L, ALT 104 U/L], which fell towards normal when he was switched to posaconazole). 17712772
Schiller DS, Fung HB. Posaconazole: an extended-spectrum triazole antifungal agent. Clin Ther 2007; 29: 1862-86. (Review of the pharmacology, safety and efficacy of posaconazole; a combined safety analysis of data from 428 patients in clinical trials found that 2% of patients discontinued therapy because of liver test abnormalities; no discussion of hepatotoxicity). 18035188
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, two cases were attributed to fluconazole, and one to ketoconazole, one to itraconazole, none to voriconazole or posaconazole). 18955056
Morris MI. Posaconazole: a new oral antifungal agent with an expanded spectrum of activity. Am J Health Syst Pharm 2009; 66: 225-36. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 8 were attributed to antifungal agents, including 4 to terbinafine, 2 to fluconazole, 1 each to ketaconazole and itraconazole, but none were linked to posaconazole). 19179636
Morris MI. Posaconazole: a new oral antifungal agent with an expanded spectrum of activity. Am J Health Syst Pharm 2009; 66: 225-36. (Review of structure, pharmacokinetics, antifungal activity, clinical use, and adverse effects; in pooled analysis from 2 trials with 428 patients, liver enzyme elevations occurred in 2% of patients; posaconazole interacts with CYP 3A4 but not other P450 enzymes). 19179636
Moton A, Krishna G, Wang Z. Tolerability and safety profile of posaconazole: evaluation of 18 controlled studies in healthy volunteers. J Clin Pharm Ther 2009; 34: 301-11. (Review of safety data from 18 clinical studies of posaconazole in 449 healthy volunteers; ALT elevations occured in 12% of posaconazole vs 6% on placebo, but none were greater than 5 times ULN). 19646076
Antifungal drugs. Treat Guidel Med Lett 2009; 7: 95-102. (Concise summary of therapy of fungal infections with recommendations on agents, dosage and duration of treatment and safety; posaconazole is similar in activity to itraconazole and has similar safety profile to fluconazole; abnormal liver function has been reported, but infrequently leads to drug discontinuation). 19940816
Wang JL, Chang CH, Young-Xu Y, Chan KA. Systematic review and meta-analysis of the tolerability and hepatotoxicity of antifungals in empirical and definitive therapy for invasive fungal infection. Antimicrob Agents Chemother 2010; 54: 2409-19. (Systematic review of 39 controlled trials in more than 8000 patients, found liver enzyme elevations in 14.5% of patients on amphotericin [pooled estimate]; 19.7% on voriconazole; 18.9% itraconazole; 10% fluconazole; 2.8% anidulafungin; 7.2% caspofungin; and 5.7% micafungin; posaconazole not discussed). 20308378
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol 2010; 70: 721-8. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, voriconazole ranked 21st with 52 cases [odds ratio 10.7] and fluconazole 30th with 42 cases [odds ratio 8.6]; no other antifungal agent listed in the top 40 causes). 21039766
Illmer T, Babatz J, Pursche S, Stölzel F, Schuler U, Schaich M, Ehninger G. Posaconazole prophylaxis during induction therapy of patients with acute lymphoblastic leukaemia. Mycoses 2011; 54: e143-7. (In a pilot study using posaconazole as prophylaxis against fungal infections in 8 patients on an intensified chemotherapy regimen, 5 developed ALT elevations [3 were above 5 times ULN], but the toxicity was transient in all and none developed hepatitis). 20337942
Raschi E, Poluzzi E, Koci A, Caraceni P, Ponti FD. Assessing liver injury associated with antimycotics: Concise literature review and clues from data mining of the FAERS database. World J Hepatol 2014; 6: 601-12. (Analysis of the FDA database on adverse reactions [2004 to 2011] identified 68,115 reports of liver injury including 1964 due to antifungal agents, the most common being terbinafine [422], fluconazole [412], voriconazole [361], amphotericin B [265], itraconazole [182], ketaconazole [94], and posaconazole [70]; among 112 cases with acute liver failure causes included fluconazole [31], terbinafine [27], voriconazole [19], ketoconazole [6], posaconazole [5], and itraconazole [4]). 25232453
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 14 cases [1.6%] were attributed to antifungal agents including 6 triazoles [3 with jaundice and 2 hospitalized, no deaths], 4 due to fluconazole, 1 ketoconazole and 1 voriconazole). 25754159
Lo Re V 3rd, Carbonari DM, Lewis JD, Forde KA, Goldberg DS, Reddy KR, Haynes K, et al. Oral azole antifungal medications and risk of acute liver injury, overall and by chronic liver disease status. Am J Med 2016; 129: 283-91. (Among 14,296 persons treated with oral ketoconazole analyzed from a Kaiser Permanente clinical database, the incidence of ALT or AST elevations above 200 U/L was 1.9% and severe acute liver injury 0.3%; one patient developed acute liver failure and required liver transplantation). 26597673
Kyriakidis I, Tragiannidis A, Munchen S, Groll AH. Clinical hepatotoxicity associated with antifungal agents. Expert Opin Drug Saf 2017; 16: 149-65. (Review of the hepatotoxicity of antifungal agents states that all antifungal agents may cause hepatic toxicity and discusses fluconazole, itraconazole, voriconazole, posaconazole and isavuconazole, but not ketoconazole). 27927037
Pettit NN, Miceli MH, Rivera CG, Narayanan PP, Perissinotti AJ, Hsu M, Delacruz J, et al. Multicentre study of posaconazole delayed-release tablet serum level and association with hepatotoxicity and QTc prolongation. J Antimicrob Chemother 2017 May 5. [Epub ahead of print] (Among 166 patients with cancer who received posaconazole at 4 major medical centers, mean serum ALT, AST and Alk P levels increased, but elevations were not associated with higher posaconazole drug levels and specific instances of liver injury were not described). 28475803
Tverdek FP, Heo ST, Aitken SL, Granwehr B, Kontoyiannis DP. Real-life assessment of the safety and effectiveness of the new tablet and intravenous formulations of posaconazole in the prophylaxis of invasive fungal infections: analysis of 343 courses. Antimicrob Agents Chemother 2017 May 15. [Epub ahead of print] (Among 172 patients treated with prophylactic posaconazole who had no preexisting liver abnormalities, 25 [15%] developed de novo liver test abnormalities [bilirubin elevations in 23 and ALT in 3] and the abnormalities were more common with higher plasma levels of posaconazole). 28507111

## OTHER REFERENCE LINKS

1. Recent References on Posaconazole: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(posaconazole)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%222010/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Posaconazole: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=posaconazole)